# Primidone

## OVERVIEW

### Introduction

Primidone is an aromatic anticonvulsant used to treat complex, partial and generalized seizures. Therapy with primidone can be associated with increases in gamma glutamyltranspeptidase levels, but is not associated with serum aminotransferase elevations, and despite its similarity in structure to phenobarbital and phenytoin, clinically apparent liver injury from primidone has not been reported and must be quite rare if it occurs at all.

### Background

Primidone (prim' i done) is a pyrimidinedione anticonvulsant and is partially metabolized to phenobarbital. Primidone is effective in suppressing seizure activity, but its mechanism of action is not well defined. It is believed to work centrally via interactions with voltage-gated sodium channels inhibiting repetitive firing of action potentials. Primidone was approved for use in epilepsy in the United States in 1954. For many years, primidone was considered a first line anticonvulsant agent, but it has been largely replaced by more recently developed anticonvulsants that are better tolerated, less sedative and have fewer long term adverse side effects. Primidone has also been used to treat essential tremor. Primidone is available as tablets of 50 and 250 mg in several generic formulations and under the brand names Mysoline, Myidone, Sertan and Apo-Primidone. The recommended initial dose for adults is 100 to 125 mg daily, increasing slowly to a maintenance dose of 250 mg three times daily. The most common side effects are dose related and include drowsiness, ataxia, diplopia, and headache. The initial dose may be associated with an acute toxic reaction with nausea, malaise, sedation, ataxia and confusion. Long term therapy may be associated with suicidal ideation and behaviors, megaloblastic anemias and birth defects.

### Hepatotoxicity

In clinical trials in epilepsy, therapy with primidone was not associated with an increased frequency of serum aminotransferase elevations or liver toxicity. Primidone therapy can lead to increases in gamma glutamyltranspeptidase (GGT) levels. Elevations in alkaline phosphatase levels were largely due to bone isoforms of the enzyme. There have been no convincing reports of hepatotoxicity due to primidone in humans and no reports of its association with acute liver failure. Interestingly, primidone appears to cause cirrhosis in dogs. Because of its similarity in structure to phenytoin and phenobarbital (aromatic anticonvulsant), it has been suspected to cross react with those agents in causing anticonvulsant hypersensitivity syndrome, but convincing case reports have not been published.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

Primidone, like phenobarbital, is extensively metabolized by the liver and can induce CYP 450 enzyme activities. Primidone can interfere with porphyrin metabolism and like phenobarbital and phenytoin can cause worsening of porphyria.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Primidone – Generic, Mysoline®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Primidone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Primidone | 125-33-7 | C12-H14-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 30 July 2020

Abbreviations used: SJS/TEN, Stevens-Johnson syndrome and toxic epidermal necrolysis.

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; mentions that there have been no reports of hepatotoxicity from primidone).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury does not specifically discuss primidone).
Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Tschudy DP, Valsamis M, Magnussen CR. (1975). Acute intermittent porphyria: clinical and selected research aspects. Ann Intern Med. (Review article on porphyria; drugs that can induce an acute exacerbation include the aromatic anticonvulsants).
Reynolds NC, Miska RM. (1981). Safety of anticonvulsants in hepatic porphyrias. Neurology. (In vitro studies showing that aromatic anticonvulsants increased intracellular hepatic delta-aminolevulinic acid [ALA] levels).
Bunch SE, Castleman WL, Hornbuckle WE, Tennant BC. (1982). Hepatic cirrhosis associated with long-term anticonvulsant drug therapy in dogs. J Am Vet Med Assoc. (Case reports of autopsies showing cirrhosis in dogs who had received long term primidone therapy).
Fichsel H, Spiess S. (1982). Klin Padiatr. (Among 69 children on primidone for >1 year and 98 controls, Alk P levels were higher [~30%] in primidone treated children, but elevations were largely in bone isoenzyme levels).
Deutsch J, Fritsch G, Gölles J, Semmelrock HJ. (1986). Effects of anticonvulsive drugs on the activity of gammaglutamyltransferase and aminotransferases in serum. J Pediatr Gastroenterol Nutr. (Among 198 children on anticonvulsants in a cross sectional study, GGT and ALT were higher in children on phenytoin; primidone was associated with mild increases in GGT but not ALT).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine and not reported to be higher on tiagabine or gabapentin; no mention of hepatotoxicity of primidone, although case of systemic lupus related to primidone is discussed).
Knowles SR, Shapiro LE, Shear NH. (1999). Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf. (Review of anticonvulsant hypersensitivity syndrome; triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant; liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; mentions that primidone may be a cause but gives no publications documenting it; nevertheless, cross reactivity among the agents can be assumed).
Hamer HM, Morris HH. (1999). Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Cleve Clin J Med. (Clinical review of anticonvulsant hypersensitivity syndrome, which occurs in 1-5/10,000 users, higher risk in African Americans and affected siblings; liver involvement common, but most cases anicteric; other manifestations include facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, interstitial nephritis: states that the syndrome occurs with primidone but without documentation).
Newell BD, Moinfar M, Mancini AJ, Nopper AJ. (2009). Retrospective analysis of 32 pediatric patients with anticonvulsant hypersensitivity syndrome (ACHSS). Pediatr Dermatol. (Among 32 children with anticonvulsant hypersensitivity syndrome the suspected cause was carbamazepine in 13, phenytoin in 12, lamotrigine in 5 and phenobarbital in 5, one patient also received primidone; hepatic involvement occurred in 90%, jaundice 18%, eosinophilia 56%, atypical lymphocytes 72%, none died).
Deuschl G, Raethjen J, Hellriegel H, Elble R. (2011). Treatment of patients with essential tremor. Lancet Neurol. (Review of therapy of essential tremor states that primidone is effective in reducing tremor in half of patients, but side effects of drowsiness and sedation are common and can be dose limiting; no mention of hepatotoxicity or ALT elevations).
(2013). Drugs for epilepsy. Treat Guidel Med Lett. (Concise review of drugs of choice for epilepsy; primidone is not discussed, but is mentioned in passing with phenobarbital as effective for partial seizures, but having a higher rate of sedation compared to other drugs).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, of which only 1 case was attributed to an anticonvulsant [phenytoin], none were attributed to primidone).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 7 [4%] of which were attributed to anticonvulsants including 3 due to phenytoin, 3 to valproate, and 1 to carbamazepine, but none to primidone).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were due to anticonvulsants including 12 due to phenytoin, 9 lamotrigine, 7 valproate, 4 carbamazepine, 3 gabapentin, 2 topiramate and 1 each for ethosuximide, fosphenytoin, and pregabalin; but none to primidone).
(2017). Drugs for epilepsy. Med Lett Drugs Ther. (Concise review of the drugs available for therapy of epilepsy lists primidone as an effective anticonvulsant that is now rarely used because of a high incidence of sedation).
Borrelli EP, Lee EY, Descoteaux AM, Kogut SJ, Caffrey AR. (2018). Stevens-Johnson syndrome and toxic epidermal necrolysis with antiepileptic drugs: An analysis of the US Food and Drug Administration Adverse Event Reporting System. Epilepsia. (Review of adverse event reports to the FDA between 2014 and 2018 identified ~2.9 million reports, 1034 for SJS/TEN, the most common class of drugs being anticonvulsants with 17 of 34 currently available anticonvulsants having at least one report, those most frequently linked being lamotrigine [n=106], carbamazepine [22], levetiracetam [14], phenytoin [14], valproate [9], clonazepam [8], zonisamide [7]; pregabalin [4], gabapentin [4] and oxcarbazepine [3], but primidone not listed; no mention of accompanying liver injury or whether attribution was as a single agent or one of several).
Cano-Paniagua A, Amariles P, Angulo N, Restrepo-Garay M. (2019). Epidemiology of drug-induced liver injury in a University Hospital from Colombia: Updated RUCAM being used for prospective causality assessment. Ann Hepatol. (Among 286 patients with liver test abnormalities seen in a single hospital in Colombia over a 1 year period, 17 were diagnosed with drug induced liver injury, the most common cause being antituberculosis therapy [n=6] followed by anticonvulsants [n=3, 1 each due to phenytoin, gabapentin and valproate]).
Wang YH, Chen CB, Tassaneeyakul W, Saito Y, Aihara M, Choon SE, Lee HY, et al., Asian Severe Cutaneous Adverse Reaction Consortium. (2019). The medication risk of Stevens-Johnson Syndrome and toxic epidermal necrolysis in Asians: the major drug causality and comparison with the US FDA label. Clin Pharmacol Ther. (Among 1028 cases of SJS/TEN reported to registries in 8 Asian countries, the most frequently implicated class of drugs was anticonvulsants including carbamazepine [26%], phenytoin [13%], lamotrigine [10%], phenobarbital [2%] and oxcarbazepine [1.7%]; no cases were attributed to primidone).

## OTHER REFERENCE LINKS

1 Recent References on Primidone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(primidone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Primidone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Primidone)